# Tecovirimat

## OVERVIEW

### Introduction

Tecovirimat is an orally available antiviral agent with activity against smallpox and other orthoviruses that is approved for use against smallpox virus (variola) infection in humans and has been used on a compassionate use basis disseminated vaccinia and monkeypox (now renamed “mpox”) infection. Tecovirimat therapy has not been linked to serum aminotransferase elevations or to instances of clinically apparent liver injury.

### Background

Tecovirimat (tec’ oh vir’ i mat) is an unique antiviral agent that has activity against a wide spectrum of orthovirus infections including smallpox, disseminated vaccinia and mpox. Tecovirimat inhibits the orthopoxvirus VP37 envelope wrapping protein, which is required for its envelopment and secretion from infected cells and is highly conserved among orthopoxviruses. Tecovirimat was discovered by high throughput screening for agents that inhibited vaccinia-virus cytopathic effects in cell culture, as a part of a major effort to identify antiviral agents active against potential bioterrorism agents including smallpox virus. Tecovirimat was found to have broad activity against orthopoxviruses including vaccinia, mpox and rabbitpox virus and was protective against fatal infection with orthopoxviruses including variola in several animal models. Because human smallpox was successfully eradicated in the 1980s, it was not possible to do trials of tecovirimat therapy for human smallpox disease, and it was ultimately approved based upon the Animal Rule which allows appropriate animal models to be used to prove efficacy and estimate the optimal human dose regimen. Safety, however, requires proof that the proposed dose regimen is well tolerated without serious toxicity in healthy human volunteers or in patients with other viral infections. In prelicensure randomized controlled trials in healthy volunteers, tecovirimat was found to be well tolerated with low rates of minor adverse events of headache, nausea, vomiting and diarrhea. Tecovirimat was approved for treatment of smallpox in 2018 and is available as capsules of 200 mg for oral therapy and as a solution for intravenous administration in single dose vials of 200 mg in 20 mL (10 mg/mL) under the commercial name TPOXX. The recommended dose in adults and children weighing 40 to 120 kg is 600 mg twice daily for 14 days and three times daily administration is recommended for adults weighing more than 120 kg. For small children the dose is based upon body weight. Longer term therapy is not recommended. Currently, tecovirimat is being actively evaluated for efficacy and safety in treating patients with disseminated vaccinia infection and mpox virus infection. Tecovirimat appears to be generally well tolerated; mild adverse events may include headache, myalgia, fatigue, gastrointestinal upset, nausea and diarrhea. Rare but potentially severe adverse events include hypersensitivity reactions, rash and embryo-fetal injury.

### Hepatotoxicity

In preregistration trials of the safety of tecovirimat in healthy adult volunteers, serum aminotransferase elevations were uncommon and mild, and were no more frequent with tecovirimat than with placebo. Furthermore, among patients treated with tecovirimat for other orthopoxvirus infections, there were no reported episodes of marked serum aminotransferase elevations or instances of clinically apparent liver injury. Thus, tecovirimat has not been shown to cause liver injury, but the total clinical experience with its use is limited.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The lack of liver injury from tecovirimat may be due to its minimal hepatic metabolism and relatively short duration of therapy. Whether longer term treatment with tecovirimat is also without serious adverse events remains to be seen. Tecovirimat is metabolized largely by hydrolysis and glucuronidation. It is a weak inducer of CYP 3A4 and mild inhibitor of CYP 2C8 and 2C19, but has few clinically significant drug-drug interactions.

### Outcome and Management

Tecovirimat has not been linked to serum aminotransferase elevations or to instances of clinically apparent liver injury. There are no recommendations for screening for or monitoring routine liver tests before or during therapy.

Drug Class: Antiviral Agents

Other Drugs in the Subclass: Brincidofovir

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tecovirimat – TPOXX®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Tecovirimat)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Tecovirimat | 869572-92-9 | C19-H15-F3-N2-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 18 October 2022

Yang G, Pevear DC, Davies MH, Collett MS, Bailey T, Rippen S, Barone L, et al. (2005). An orally bioavailable antipoxvirus compound (ST-246) inhibits extracellular virus formation and protects mice from lethal orthopoxvirus Challenge. J Virol. (Initial report of the discovery and characterization of tecovirimat [formerly ST-246] identified by high throughput screening for activity against vaccinia virus cytopathic effects in cell culture, which was shown to inhibit the highly conserved V061 [VP37] envelope wrapping protein that is required for production of extracellular orthopoxvirus and which decreased serum levels of several orthopoxviruses in infected animals, improving survival and protecting mice from orthopoxvirus induced disease).
Jordan R, Leeds JM, Tyavanagimatt S, Hruby DE. (2010). Development of ST-246® for treatment of poxvirus infections. Viruses. (Review of the development of tecovirimat, discovered by high throughput screening for inhibitors of vaccinia virus cytopathic effects in cell culture which was found to protect animals from lethal orthopoxvirus challenge, and which is orally available and well tolerated in human volunteers).
Chinsangaram J, Honeychurch KM, Tyavanagimatt SR, Leeds JM, Bolken TC, Jones KF, Jordan R, et al. (2012). Safety and pharmacokinetics of the anti-orthopoxvirus compound ST-246 following a single daily oral dose for 14 days in human volunteers. Antimicrob Agents Chemother. (Among 107 healthy volunteers treated with tecovirimat [400 or 600 mg twice daily for 14 days], therapy was safe and well tolerated with only mild nausea and headache and no change in routine laboratory test results including serum aminotransferase levels).
Mucker EM, Goff AJ, Shamblin JD, Grosenbach DW, Damon IK, Mehal JM, Holman RC, et al. (2013). Efficacy of tecovirimat (ST-246) in nonhuman primates infected with variola virus (Smallpox). Antimicrob Agents Chemother. (Among 18 cynomolgus macaques inoculated with a fatal dose of smallpox virus [variola] and treated with tecovirimat or placebo for 14 days starting on day 2 or 4, all animals were infected but those on tecovirimat had reduced levels of virus, lower total pox lesion counts [<500 vs >1000], and survived with full recovery while 3 of 6 placebo treated animals died and the other 3 had persistence of pox lesions at 28 days).
Berhanu A, Prigge JT, Silvera PM, Honeychurch KM, Hruby DE, Grosenbach DW. (2015). Treatment with the smallpox antiviral tecovirimat (ST-246) alone or in combination with ACAM2000 vaccination is effective as a postsymptomatic therapy for monkeypox virus infection. Antimicrob Agents Chemother. (Among 32 cynomolgus macaques inoculated with a fatal dose of mpox virus and treated within 3 days with smallpox vaccination [ACAM2000], tecovirimat, both or with placebo alone, all tecovirimat treated animals survived while smallpox vaccine alone had no effect; delaying tecovirimat to days 4 or 5 provided partial survival benefits and all animals that survived were protected against re-challenge).
Hoy SM. (2018). Tecovirimat: first global approval. Drugs. (Review of the structure, mechanism of action, history of development, efficacy and safety of tecovirimat shortly after its approval for treatment with human smallpox infection in the US based upon its efficacy in preventing and treating mpox and rabbitpox challenge in animals and its safety in studies of its pharmacokinetics and tolerance in human volunteers).
Russo AT, Grosenbach DW, Brasel TL, Baker RO, Cawthon AG, Reynolds E, Bailey T, et al. (2018). Effects of treatment delay on efficacy of tecovirimat following lethal aerosol monkeypox virus challenge in cynomolgus macaques. J Infect Dis. (Among 62 cynomolgus macaques inoculated with a lethal dose of mpox virus and treated with tecovirimat starting 1 to 8 days later, survival was 100% in animals started within 5 days of inoculation and was reduced with further delay [50% to 100% survival]; no mention of hepatotoxicity).
Grosenbach DW, Honeychurch K, Rose EA, Chinsangaram J, Frimm A, Maiti B, Lovejoy C, et al. (2018). Oral tecovirimat for the treatment of smallpox. N Engl J Med. (Summary of studies of tecovirimat in animal models of orthopoxvirus infections and human trials of pharmacokinetics and safety mentions that the most common adverse events in healthy human volunteers was headache [17%] and gastrointestinal symptoms [15%] including nausea and diarrhea; no mention of ALT elevations or hepatotoxicity).
Laudisoit A, Tepage F, Colebunders R. (2018). Oral tecovirimat for the treatment of smallpox. N Engl J Med. (Letter to the editor in response to Grosenbach [2018] suggesting that tecovirimat be used to treat mpox virus infection, which occurs in several countries of Central and West Africa with more than 100 cases annually in the Republic of the Congo and with a mortality rate of 10%, its rising incidence perhaps being related in part to discontinuation of smallpox vaccination after its global eradication).
Chan-Tack KM, Harrington PR, Choi SY, Myers L, O'Rear J, Seo S, McMillan D, et al. (2019). Assessing a drug for an eradicated human disease: US Food and Drug Administration review of tecovirimat for the treatment of smallpox. Lancet Infect Dis. (Summary of the basis of FDA approval of tecovirimat based upon requirements of the Animal Rule with rigorous proof of its efficacy in appropriate animal models and evidence of safety in carefully conducted studies in 359 healthy volunteers).
Lindholm DA, Fisher RD, Montgomery JR, Davidson W, Yu PA, Yu YC, Burgado J, et al. (2019). Preemptive tecovirimat use in an active duty service member who presented with acute myeloid leukemia after smallpox vaccination. Clin Infect Dis. (19 year old US Airforce inductee was given smallpox vaccine and soon thereafter found to have evidence of vaccinia pox lesions and previously undiagnosed acute myelogenous leukemia, for which reasons he was given tecovirimat [600 mg twice daily for 62 days] under an expanded assessment program, which he tolerated without obvious adverse reactions attributable to tecovirimat; no mention of ALT elevations or hepatotoxicity).
Russo AT, Berhanu A, Bigger CB, Prigge J, Silvera PM, Grosenbach DW, Hruby D. (2020). Co-administration of tecovirimat and ACAM2000™ in non-human primates: Effect of tecovirimat treatment on ACAM2000 immunogenicity and efficacy versus lethal monkeypox virus challenge. Vaccine. (In studies of mpox virus infection in macaques, the coadministration of tecovirimat with a live attenuated smallpox vaccine was associated with a reduced lesion response to the vaccine and partial reduction in efficacy of the vaccine, suggesting that tecovirimat by inhibiting the attenuated vaccinia virus infection caused by vaccination may also attenuate its efficacy).
Rao AK, Schulte J, Chen TH, Hughes CM, Davidson W, Neff JM, Markarian M, et al., July 2021 Monkeypox Response Team. (2022). Monkeypox in a traveler returning from Nigeria – Dallas, Texas, July 2021. MMWR Morb Mortal Wkly Rep. (Case report of a middle aged man who developed fever, fatigue, cough and rash during travel in Nigeria and who presented with an extensive pustular rash 4 days after return to the United States where a West African clade of mpox virus was identified from a swab of a lesion; this being the first imported case of mpox virus infection in the US; follow up found no secondary cases in contacts).
Adler H, Gould S, Hine P, Snell LB, Wong W, Houlihan CF, Osborne JC, et al. (2022). NHS England High Consequence Infectious Diseases (Airborne) Network. Clinical features and management of human monkeypox: a retrospective observational study in the UK. Lancet Infect Dis. (Among 7 patients diagnosed with mpox disease in the UK between 2018 and 2021, 3 were treated with brincidofovir [200 mg given as 3 weekly doses], all of whom developed ALT elevations [331, 550 and 127 U/L, without jaundice] and did not complete therapy, while 1 patient received tecovirimat [600 mg twice daily for 2 weeks], with rapid resolution of rash and clearance of virus; all patients ultimately recovered).
Matias WR, Koshy JM, Nagami EH, Kovac V, Moeng LR, Shenoy ES, Hooper DC, et al. Tecovirimat for the treatment of human monkeypox: an initial series from Massachusetts, United States. Open Forum Infect Dis. 2022;9:ofac377. (Among 3 patients with mpox virus infection presenting in Boston in Spring 2022 who were treated with tecovirimat [600 mg twice daily for 14 days], all had clinical improvements within 2-4 days and ultimately recovered; monitoring of biochemical tests found mild ALT elevations in one patient [peak 72 U/L] that resolved even without discontinuation or dose adjustment).
O'Shea J, Filardo TD, Morris SB, Weiser J, Petersen B, Brooks JT. (2022). Interim guidance for prevention and treatment of monkeypox in persons with HIV infection – United States, August 2022. MMWR Morb Mortal Wkly Rep. (Guidance for prevention and treatment of mpox virus infections in persons with HIV infection from the Centers for Disease Control and Prevention [CDC] in response to the multinational outbreak of mpox virus infections in May 2022; discussion of tecovirimat does not mention ALT elevations or hepatotoxicity).
Sherwat A, Brooks JT, Birnkrant D, Kim P. (2022). Tecovirimat and the treatment of monkeypox – past, present, and future considerations. N Engl J Med. (Editorial from the FDA, NIH and CDC on the need for rapidly initiated randomized controlled trials of tecovirimat for human mpox virus infection).
Rizk JG, Lippi G, Henry BM, Forthal DN, Rizk Y. (2022). Prevention and treatment of monkeypox. Drugs. (Review of the prevention and treatment of mpox virus infection mentions 2 live virus vaccines against smallpox [JYNNEOS and ACAM2000] that are approximately 85% effective against mpox; and discusses 4 antiviral agents [tecovirimat, cidofovir, brincidofovir, and vaccinia immune globulin] which are not formally approved for use in mpox can be obtained under IND or emergency access programs; mentions that brincidofovir can cause serum aminotransferase and bilirubin elevations).
Siegrist EA, Sassine J. Antivirals with activity against monkeypox: a clinically oriented review. Clin Infect Dis. 2022 Jul 29:ciac622. Epub ahead of print. (Review of the efficacy and safety of three drugs with activity against mpox virus infection that are available in the US [cidofovir, brincidofovir and tecovirimat] mentions the superior activity of tecovirimat, the major adverse drug reactions of which being headache, abdominal pain, nausea, vomiting, dry mouth and hypersensitivity reactions).
Lucar J, Roberts A, Saardi KM, Yee R, Siegel MO, Palmore TN. (2022). Monkeypox virus-associated severe proctitis treated with oral tecovirimat: a report of two cases. Ann Intern Med. (Description of 2 patients from Washington DC with mpox virus infection and severe pox lesions including proctitis treated with tecovirimat, both responding clinically within 2 days of starting therapy, one patient without any adverse events and one with mild fatigue only; no mention of ALT elevations or hepatotoxicity).
Desai AN, Thompson GR, Neumeister SM, Arutyunova AM, Trigg K, Cohen SH. (2022). Compassionate use of tecovirimat for the treatment of monkeypox infection. JAMA. (Among 25 adult men with clinically apparent and confirmed mpox virus infection treated with tecovirimat [usually 600 mg twice daily for 14 days], treatment “was generally well tolerated”, adverse events included fatigue, headache, nausea, itching and diarrhea; no mention of ALT elevations or hepatotoxicity).
See KC. (2022). Vaccination for monkeypox virus infection in humans: a review of key considerations. Vaccines (Basel). (Review of the clinical features, epidemiology, prevention and treatment of mpox virus infection discusses tecovirimat, brincidofovir and vaccinia immunoglobulin; mentions that brincidofovir therapy is associated with ALT elevations and has the potential for carcinogenesis, while not mentioning adverse events attributed to tecovirimat or vaccinia immunoglobulin).
(2022). Prevention and treatment of monkeypox. Med Lett Drugs Ther. (Concise review on the global outbreak of mpox disease in 2022 that was associated with human-to-human transmission, most frequently in men who have sex with men, and a summary of prevention [vaccination with ACAM2000 or Jynneos, which are live vaccinia virus vaccines approved for prevention of smallpox], and treatment [two agents that are approved as therapy of smallpox which are available under an expanded access protocol for mpox]).

## OTHER REFERENCE LINKS

1 Recent References on Tecovirimat: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Tecovirimat/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Tecovirimat: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tecovirimat)